# Macular Degeneration Agents

## OVERVIEW

### Introduction

Macular degeneration is an age-related disease of the retina marked by progressive loss of central visual acuity. It is the major cause of visual loss above the age of 60 and risk factors include family history, smoking, being overweight or obese, and hypertension. Age-related macular degeneration occurs in two forms: “dry” and “wet”.

Dry macular degeneration accounts for 80% to 90% of cases and is caused by thinning of the retina, retinal cell loss, and subretinal accumulation of abnormal protein in clumps (drusen). In advanced forms there is patchy atrophy, referred to as geographic atrophy. Recently, agents have been developed for treatment of age-related dry macular degeneration with geographic atrophy. Approved agents include drugs that inhibit complement activation (avacincaptad pegol and pegcetacoplan). The agents are given by intravitreal injections every 1 to 2 months.

Wet macular degeneration accounts for 10% to 20% of cases and is due to neovascularization in the subretinal space with abnormal and leaky blood vessels. The vascularization is dependent, at least in part, on action of vascular endothelial growth factor (VEGF). Wet macular degeneration is treatable with agents that specifically target VEGF which, when given as intravitreal injections, slow the progression of (but do not cure) the neovascularization. These include monoclonal antibodies to VEGF (bevacizumab, brolucizumab, ranibizumab, faricimab), aptamers (small oligonucleotides that bind to VEGF: pegaptanib), and fusion VEGF receptor proteins that act as a decoy of the circulating growth factor (aflibercept). The agents are given as intravitreal injections every 4 to 8 weeks.

Most adverse events of these agents are ocular and relate to their local injection. Systemic exposure is limited and ex-ocular adverse events are rare. Some of the agents have been implicated in cardiovascular or cerebrovascular thromboembolic events, but these are uncommon. None of the drugs for macular degeneration have been implicated in causing hepatotoxicity, either serum enzyme elevations during treatment or clinically apparent liver injury, at least when administered by intravitreal injection. The lack of hepatotoxicity is probably due largely to the lack of significant systemic absorption and exposure. When given intravenously as therapy of neoplastic conditions, several have been linked to rare instances of liver injury.

### Aflibercept

Aflibercept (a flib’ er sept) is a unique fusion protein consisting of VEGF receptors 1 and 2 fused to the Fc portion of IgG that acts as a decoy receptor that competes for the binding of endogenous VEGF. It was approved for use in neovascular age-related macular degeneration and for macular edema after central retinal vein occlusion in 2011. Indications have been broadened and aflibercept is approved for use also for diabetic macular edema and retinopathy and for the retinopathy of prematurity. Aflibercept is available in single use vials of 2 mg/0.05 mL generically (as biosimilars) and under the brand name Eylea. The recommended dose is 2 mg by intravitreal injection in each affected eye every 4 weeks for the first 3 doses and every 8 weeks thereafter. In 2023, a high dose formulation (Eylea HD) was approved, available in single use vials of 8 mg/0.07 mL that can be administered every 4 weeks for the first 3 doses and every 8 to 16 weeks thereafter.

Aflibercept is also available in a form for parenteral administration (ziv-aflibercept: Zaltrap), which is approved for use in combination with other antineoplastic agents (fluorouracil, leucovorin and irinotecan: FOLFIRI) for metastatic colon cancer. Administration of FOLFIRI is associated with fairly high rates of serum ALT and AST elevations and with occasional liver related serious adverse events. The addition of ziv-aflibercept to FOLFIRI has not been associated with higher rates of either serum enzyme elevations or clinically apparent liver injury, but experience with this combination has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury when given in low doses by intravitreal injection).

### Bevacizumab

Bevacizumab (bev’ a ciz” ue mab) is a humanized monoclonal antibody to VEGF that is approved for use intravenously for metastatic colon, renal cell, non-small cell lung, cervical, ovarian, all fallopian tube cancer and for brain glioblastoma and hepatocellular carcinoma. Bevacizumab has been used off label to treat macular degeneration and, in controlled trials, was as effective as ranibizumab in improving or stabilizing vision in persons with age-related neovascular (wet) macular degeneration. Bevacizumab is available in vials of 100 mg in 4 mL and 400 mg 16 mL in a concentration of 25 mg/mL generically (as biosimilars) and under the brand name Avastin. The dosage used off label for macular degeneration is 1.25 mg (0.05 mL) by intravitreal injection in each affected eye every 4 weeks.

Likelihood score: E (unlikely cause of clinically apparent liver injury when given in low doses by intravitreal injection).

### Brolucizumab

Brolucizumab (broe’ lue siz” ue mab) is a recombinant humanized monoclonal antibody fragment (Fab) to VEGF (similar to bevacizumab). It was approved for use in neovascular (wet) age-related macular degeneration and diabetic macular edema in 2019. Brolucizumab is available in single use vials of 6 mg in 0.05 mL under the brand name Beovu. The recommended dose is 6 mg by intravitreal injection in each affected eye every 4 weeks for 3 to 5 doses followed by once every 8 to 12 weeks.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Faricimab

Faricimab (far ik” i mab) is a bispecific, human monoclonal antibody to both vascular endothelial growth factor (VEGF) and angiopoietin-2 (Ang-2), a cell surface protein involved in the pathway of maintaining vascular homeostasis. Faricimab has been shown to be non-inferior to aflibercept in preventing progression and improving visual acuity in both neovascular (wet) macular degeneration and diabetic macular edema. Faricimab was approved for therapy of these two forms of macular disease in 2022. It is available in single use vials of 6 mg in 0.05 mL (300 mg/mL) under the brand name Vabysmo. The recommended dose is 6 mg by intravitreal injection in each affected eye every 4 weeks for 4 doses followed by variable dosing regimens based upon indication and disease severity for up to 48 weeks.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Pegaptanib

Pegaptanib (peg ap’ ta nib) is a pegylated aptamer, a modified oligonucleotide which binds with and inactivates extracellular VEGF. It was approved for use in neovascular (wet) age-related macular degeneration in 2004. Pegaptanib was available in single use glass syringes of 0.3 mg/90 μL under the brand name Macugen. The recommended dose was 0.3 mg by intravitreal injection in each affected eye every six weeks. Pegaptanib was subsequently withdrawn from the United States by the sponsor because of poor performance in the face of competing products, but it may be still available abroad.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Ranibizumab

Ranibizumab (ra’ ni biz” ue mab) is a recombinant humanized monoclonal antibody fragment (Fab) to VEGF (similar to bevacizumab). It was approved for use in neovascular (wet) age-related macular degeneration, macular edema following retinal vein occlusion and diabetic macular edema in 2006. Indications have subsequently expanded to other causes of wet macular degeneration. Ranibizumab is available in single use syringes designed to provide 0.5 mg in 0.05 mL (10mg/mL) or 0.3 mg in 0.05 mL (6 mg/mL) under the brand name Lucentis as well as generically as equivalent biosimilars. The recommended dose is 0.5 mg by intravitreal injection in each affected eye every 4 weeks which may be extended to less frequent dosing after 4 doses. The dosage for diabetic macular edema is 0.3 mg every 4 weeks.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Avacincaptad pegol

Avacincaptad (a’ va sin kap” tad) pegol is a pegylated RNA aptamer than binds to and inactivates complement factor C5 preventing its cleavage and decreasing the activation of complement and formation of membrane attachment complexes. In placebo controlled clinical trials, monthly intravitreal injections of avacincaptad were associated with a decrease in growth of geographic atrophy due to dry macular degeneration. It was approved for use geographic atrophy in 2023. Avacincaptad is available in single use vials of 2 mg in 0.1 mL (20 mg/mL) under the brand name Izervay. The recommended dose is 2 mg by intravitreal injection in each affected eye once monthly for up to 12 months.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Pegcetacoplan

Pegcetacoplan (peg set” a koe’ plan) consists of two identical 15-amino acid peptides joined by a molecule of polyethylene glycol and acts as an inhibitor of complement C3 blocking complement activation at an early step in the cascade. Pegcetacoplan is used mainly as therapy of paroxysmal nocturnal hemoglobinuria (PNH) given subcutaneously twice weekly in 30 mL infusions (Empaveli: approved 2021). When given in small doses by intravitreal injection, pegcetacoplan has been shown to decrease the growth of geographic atrophy in age-related macular degeneration. Pegcetacoplan was approved for therapy of dry macular degeneration with geographic atrophy in 2023. It is available in single use vials of 15 mg in 0.1 mL (150 mg/mL) under the brand name Syfovre. The recommended dose is 15 mg by intravitreal injection in each affected eye every 25 to 60 days.

Likelihood score: E (unlikely cause of clinically apparent liver injury when given in low doses by intravitreal injection).

Drug Class: Macular Degeneration Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aflibercept – Eylea®

Bevacizumab – Avastin®

Brolucizumab – Beovu®

Faricimab – Vabysmo®

Pegaptanib – Macugen®

Ranibizumab – Lucentis®

Avacincaptad pegol – Izervay®

Pegcetacoplan – Syfovre®

DRUG CLASS

Macular Degeneration Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aflibercept) – Aflibercept

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bevacizumab) – Bevacizumab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brolucizumab) – Brolucizumab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Faricimab) – Faricimab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pegaptanib) – Pegaptanib [Withdrawn}

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ranibizumab) – Ranibizumab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Avacincaptad%20pegol) – Avacincaptad pegol

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pegcetacoplan) – Pegcetacoplan

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Aflibercept | 862111-32-8 | Aberrant Angiogenesis Inhibitor | Not Available
Bevacizumab | 216974-75-3 | Monoclonal Antibody | Not Available
Brolucizumab | 1531589-13-5 | Monoclonal Antibody | Not Available
Faricimab | 1607793-29-2 | Monoclonal Antibody | Not Available
Pegaptanib | 222716-86-1 | Ribonucleic Acid Aptamer | Not Available
Ranibizumab | 347396-82-1 | Monoclonal Antibody | Not Available
Avacincaptad | 1613641-69-2 | Complement C5 Inhibitor | Not Available
Pegcetacoplan | 2019171-69-6 | Complement C3 Inhibitor | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 31 July 2024

Henderer JD, Rapuano CJ. Treatment of retinal neovascularization, macular degeneration, and vitreomacular traction. Ocular pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1266-1267. (Textbook of pharmacology and therapeutics).
Cunningham ET Jr, Adamis AP, Altaweel M, Aiello LP, Bressler NM, D'Amico DJ, Goldbaum M, et al.; Macugen Diabetic Retinopathy Study Group. A phase II randomized double-masked trial of pegaptanib, an anti-vascular endothelial growth factor aptamer, for diabetic macular edema. Ophthalmology 2005; 112: 1747-57. (Among 172 patients with diabetic macular edema treated with intraocular pegaptanib or sham injections for 20 weeks, visual acuity was more likely to be improved or stable with pegaptanib, and adverse events were uncommon and largely due to the intravitreal injections). 16154196
Pegaptanib sodium (Macugen) for macular degeneration. Med Lett Drugs Ther 2005; 47: 55-6. (Concise review of the mechanism of action, efficacy, safety and cost of pegaptanib shortly after its approval in the US mentions that intraocular pegaptanib and bevacizumab may be associated with a higher rate of cardiovascular and cerebrovascular thromboses due to their inhibitory effects on angiogenesis). 15988400
Ranibizumab (Lucentis) for macular degeneration. Med Lett Drugs Ther 2006; 48: 85-6. (Concise review of the mechanism of action, efficacy, safety and costs of ranibizumab shortly after its approval for use in the US, along with comparison to other agents used in macular degeneration including bevacizumab and pegaptanib). 17051134
de Jong PT. Age-related macular degeneration. N Engl J Med 2006; 355: 1474-85. (Review of the clinical features, course and outcome, pathogenesis and risk factors for age-related macular degeneration). 17021323
Avery RL, Pieramici DJ, Rabena MD, Castellarin AA, Nasir MA, Giust MJ. Intravitreal bevacizumab (Avastin) for neovascular age-related macular degeneration. Ophthalmology. 2006; 113(3): 363-72.e5. (Among 79 patients with age-related macular degeneration treated with bevacizumab by intravitreal injection monthly, there were no significant systemic side effects). 16458968
VEGF Inhibition Study in Ocular Neovascularization (V.I.S.I.O.N.) Clinical Trial Group, D'Amico DJ, Masonson HN, Patel M, Adamis AP, Cunningham ET Jr, Guyer DR, Katz B. Pegaptanib sodium for neovascular age-related macular degeneration: two-year safety results of the two prospective, multicenter, controlled clinical trials. Ophthalmology 2006; 113: 992-1001.e6. (Among 147 patients with age-related macular degeneration treated with varying doses of pegaptanib for 54 weeks, ocular adverse events were common, but usually mild-to-moderate, while nonocular events were uncommon and there was no evidence of systemic toxicity). 16647134
Rosenfeld PJ, Brown DM, Heier JS, Boyer DS, Kaiser PK, Chung CY, Kim RY; MARINA Study Group. Ranibizumab for neovascular age-related macular degeneration. N Engl J Med 2006; 355: 1419-31. (Among 716 patients with neovascular age-related macular degeneration, average visual acuity at 24 months improved in ranibizumab treated subjects, but decreased in controls; no mention of ALT changes or hepatotoxicity). 17021318
Kourlas H, Abrams P. Ranibizumab for the treatment of neovascular age-related macular degeneration: a review. Clin Ther 2007; 29: 1850-61. (Review and summary of 3 clinical trials of ranibizumab for macular degeneration mentions that nonocular adverse events were uncommon and similar in frequency in standard of care and ranibizumab treated subjects; no mention of ALT elevations or hepatotoxicity). 18035187
Macugen AMD Study Group, Apte RS, Modi M, Masonson H, Patel M, Whitfield L, Adamis AP. Pegaptanib 1-year systemic safety results from a safety-pharmacokinetic trial in patients with neovascular age-related macular degeneration. Ophthalmology 2007; 114: 1702-12. (Among 147 patients with neovascular age-related macular degeneration from two clinical studies receiving varying high doses of pegaptanib by intravitreal injection for up to 54 weeks, nonocular adverse events were uncommon and there was no evidence of systemic toxicity). 17509689
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to agents used to treat macular degeneration). 18955056
Do DV, Nguyen QD, Shah SM, Browning DJ, Haller JA, Chu K, Yang K, et al. An exploratory study of the safety, tolerability and bioactivity of a single intravitreal injection of vascular endothelial growth factor Trap-Eye in patients with diabetic macular oedema. Br J Ophthalmol 2009; 93: 144-9. (Pilot study of a single intravitreal injection of aflibercept in 5 patients with diabetes and macular degeneration showed clinical improvements in 4 patients and no systemic effects). 19174400
Wroblewski JJ, Wells JA 3rd, Adamis AP, Buggage RR, Cunningham ET Jr, Goldbaum M, Guyer DR, et al.; Pegaptanib in Central Retinal Vein Occlusion Study Group. Pegaptanib sodium for macular edema secondary to central retinal vein occlusion. Arch Ophthalmol 2009; 127: 374-80. (Among 98 patients with macular edema from central retinal vein occlusion treated with pegaptanib or sham intravitreal injections, visual acuity tended to be better among the pegaptanib treated patients and there was "no evidence of an increased risk of systemic adverse events"). 19365011
Tufail A, Patel PJ, Egan C, Hykin P, da Cruz L, Gregor Z, Dowler J, et al.; ABC Trial Investigators. Bevacizumab for neovascular age related macular degeneration (ABC Trial): multicentre randomised double masked study. BMJ 2010; 340: c2459. (Among 131 patients with neovascular macular degeneration, improved vision at one year occurred in 32% of bevacizumab vs 3% of standard therapy treated subjects and side effects were largely related to the intravitreal injections). 20538634
Sultan MB, Zhou D, Loftus J, Dombi T, Ice KS; Macugen 1013 Study Group. A phase 2/3, multicenter, randomized, double-masked, 2-year trial of pegaptanib sodium for the treatment of diabetic macular edema. Ophthalmology 2011; 118 1107-18. (Among 282 patients with diabetic macular edema treated with pegaptanib or placebo for up to 2 years, there were no differences in nonocular adverse events between the two groups). 21529957
Martin DF, Maguire MG, Ying GS, Grunwald JE, Fine SL, Jaffe GJ. Ranibizumab and bevacizumab for neovascular age-related macular degeneration. N Engl J Med 2011; 364: 1897-1908. (Among 1208 patients with neovascular age-related macular degeneration, ranibizumab and bevacizumab had similar effects on visual acuity and systemic adverse effects were uncommon; no mention of ALT elevations or hepatotoxicity). 21526923
Comparison of Age-related Macular Degeneration Treatments Trials (CATT) Research Group, Martin DF, Maguire MG, Fine SL, Ying GS, Jaffe GJ, Grunwald JE, Toth C, et al. Ranibizumab and bevacizumab for treatment of neovascular age-related macular degeneration: two-year results. Ophthalmology 2012; 119: 1388-98. (Among 1107 patients who were followed during year 2 of ranibizumab or bevacizumab therapy for neovascular age-related macular degeneration, systemic adverse events could not be definitely linked to the intravitreal injections of anti-VEGF therapy; no mention of ALT elevations or hepatotoxicity). 22555112
Heier JS, Brown DM, Chong V, Korobelnik JF, Kaiser PK, Nguyen QD, Kirchhof B, et al.; VIEW 1 and VIEW 2 Study Groups. Intravitreal aflibercept (VEGF trap-eye) in wet age-related macular degeneration. Ophthalmology 2012; 119(12): 2537-48. (Among 2419 patients with neovascular age-related macular degeneration treated with intravitreal injections of aflibercept or ranibizumab, response rates were similar with the two drugs and the incidence of systemic adverse events was similar; no mention of ALT elevations or hepatotoxicity). 23084240
Tang PA, Cohen SJ, Kollmannsberger C, Bjarnason G, Virik K, MacKenzie MJ, Lourenco L, et al. Phase II clinical and pharmacokinetic study of aflibercept in patients with previously treated metastatic colorectal cancer. Clin Cancer Res 2012; 18: 6023-31. (Among 75 patients with metastatic colorectal cancer treated with aflibercept, few had an objective response and adverse events included fatigue, hypertension and proteinuria; no mention of ALT elevations or hepatotoxicity). 22977191
Ho AC, Scott IU, Kim SJ, Brown GC, Brown MM, Ip MS, Recchia FM. Anti-vascular endothelial growth factor pharmacotherapy for diabetic macular edema: a report by the American Academy of Ophthalmology. Ophthalmology 2012; 119: 2179-88. (Systematic review of safety and efficacy of anti-VEGF therapies of diabetic macular edema mentions that there is no greater risk of systemic adverse events from intravitreal infusions of anti-VEGF therapies including bevacizumab, ranibizumab, pegaptanib and aflibercept). 22917890
Aflibercept (Eylea) for age-related macular degeneration. Med Lett Drugs Ther 2012; 54: 9-10. (Concise review of the mechanism of action, efficacy, safety and costs of aflibercept shortly after its approval in the US mentions that adverse events were virtually identical to ranibizumab and largely ophthalmologic). 22354219
Gotlieb WH, Amant F, Advani S, Goswami C, Hirte H, Provencher D, Somani N, et al. Intravenous aflibercept for treatment of recurrent symptomatic malignant ascites in patients with advanced ovarian cancer: a phase 2, randomised, double-blind, placebo-controlled study. Lancet Oncol 2012; 13: 154-62. (Among 55 women with advanced ovarian cancer and ascites treated with intravenous aflibercept or placebo, side effects included fatigue and dehydration; ALT elevations occurred in 10% of aflibercept, but no placebo recipient and one patient developed both ALT and bilirubin elevations during first 30 days of therapy). 22192729
Mackay HJ, Buckanovich RJ, Hirte H, Correa R, Hoskins P, Biagi J, Martin LP, et al. A phase II study single agent of aflibercept (VEGF Trap) in patients with recurrent or metastatic gynecologic carcinosarcomas and uterine leiomyosarcoma. A trial of the Princess Margaret Hospital, Chicago and California Cancer Phase II Consortia. Gynecol Oncol 2012; 125: 136-40. (Among 63 women with gynecologic soft tissue sarcomas who were treated with intravenous aflibercept, no objective responses occurred and side effects were common; 6 [10%] patients had mild Alk P elevations, but there was no mention of ALT elevations or hepatotoxicity). 22138373
Heier JS, Clark WL, Boyer DS, Brown DM, Vitti R, Berliner AJ, Kazmi H, et al. Intravitreal aflibercept injection for macular edema due to central retinal vein occlusion: two-year results from the COPERNICUS Study. Ophthalmology 2014; 121 (7): 1414-1420.e1. (Among 188 patients with macular edema due to central retinal vein occlusion for up to 2 years, improvement in visual acuity was greater with aflibercept than sham intravitreal injections, and rates of nonocular adverse events were similar; ALT elevations and hepatotoxicity were not mentioned). 24679444
Semeraro F, Morescalchi F, Duse S, Gambicorti E, Romano MR, Costagliola C. Systemic thromboembolic adverse events in patients treated with intravitreal anti-VEGF drugs for neovascular age-related macular degeneration: an overview. Expert Opin Drug Saf 2014; 13: 785-802. (Review of the evidence for systemic absorption of anti-VEGF agents used in ophthalmology and their possible adverse effects, focusing upon thromboembolic cardiovascular and cerebrovascular events). 24809388
Perkins SL, Cole SW. Ziv-aflibercept (Zaltrap) for the treatment of metastatic colorectal cancer. Ann Pharmacother 2014; 48: 93-8. (Review of efficacy and safety of aflibercept as therapy of metastatic colorectal cancer does not include ALT elevations or hepatotoxicity in list of adverse events occurring in more than 10% of patients). 24259608
Schmidt-Erfurth U, Kaiser PK, Korobelnik JF, Brown DM, Chong V, Nguyen QD, Ho AC, et al. Intravitreal aflibercept injection for neovascular age-related macular degeneration: ninety-six-week results of the VIEW studies. Ophthalmology 2014; 121: 193-201. (Among 2457 patients with neovascular age-related macular degeneration, improvement and stability of visual acuity was similar with intravitreal injections of aflibercept and ranibizumab, and nonocular adverse events were similar). 24084500
Korobelnik JF, Holz FG, Roider J, Ogura Y, Simader C, Schmidt-Erfurth U, Lorenz K, et al.; GALILEO Study Group. Intravitreal aflibercept injection for macular edema resulting from central retinal vein occlusion: one-year results of the phase 3 GALILEO study. Ophthalmology 2014; 121: 202-8. (Among 177 patients with macular edema due to central retinal vein occlusion, visual acuity improved with aflibercept and nonocular adverse events were similar in the sham and aflibercept treated subjects; no mention of hepatotoxicity). 24084497
Chang AA, Broadhead GK, Hong T, Joachim N, Syed A, Schlub TE, Toth L, et al. Intravitreal aflibercept for treatment-resistant neovascular age-related macular degeneration: 12-month safety and efficacy outcomes. Ophthalmic Res 2015; 55: 84-90. (Among 49 patients with macular degeneration treated with intravitreal aflibercept every 1 to 2 months for 1 year, there were 22 serious adverse events, but none were liver related). 26637166
Brown DM, Schmidt-Erfurth U, Do DV, Holz FG, Boyer DS, Midena E, Heier JS, et al. intravitreal aflibercept for diabetic macular edema: 100-week results from the VISTA and VIVID Studies. Ophthalmology 2015; 122: 2044-52. (Among 872 patients treated with intravitreal aflibercept every 4 or 8 weeks or with laser photocoagulation for up to 2 years, adverse event rates including myocardial infarction and stroke were similar in all three groups; no mention of liver related adverse events). 26198808
Scott LJ, Chakravarthy U, Reeves BC, Rogers CA. Systemic safety of anti-VEGF drugs: a commentary. Expert Opin Drug Saf 2015; 14: 379-88. (Review of trials of different anti-VEGF agents for macular degeneration found no increase in rates of all-cause mortality as well as arterio-thrombotic and gastrointestinal serious adverse events; no specific mention of hepatotoxicity). 25489638
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to drugs used to treat macular degeneration). 25754159
Ziemssen F, Sobolewska B, Deissler H, Deissler H. Safety of monoclonal antibodies and related therapeutic proteins for the treatment of neovascular macular degeneration: addressing outstanding issues. Expert Opin Drug Saf 2016; 15: 75-87. (Review of safety of monoclonal anti-VEGF therapy of macular degeneration states that systemic levels and effects are detectable after intravitreal injections and that extra-ocular serious adverse effects may include cerebrovascular events; no mention of hepatotoxicity). 26568279
Avery RL, Gordon GM. Systemic Safety of prolonged monthly anti-vascular endothelial growth factor therapy for diabetic macular edema: a systematic review and meta-analysis. JAMA Ophthalmol 2016; 134: 21-9. (Metaanalysis of 4 controlled trials of long term intravitreal anti-VEGF therapy of diabetic macular edema found increased risk for arterio-thrombotic events and death, occurring in 30 of 791 [4%] treated vs 7 of 537 [1.3%] controls; no mention of hepatotoxicity). 26513684
Kitchens JW, Do DV, Boyer DS, Thompson D, Gibson A, Saroj N, Vitti R, et al. Comprehensive review of ocular and systemic safety events with intravitreal aflibercept injection in randomized controlled trials. Ophthalmology 2016; 123: 1511-20. (Review of safety outcomes from more than 4000 patients enrolled in 10 controlled trials of intravitreal aflibercept therapy of macular degeneration, found no increase in systemic adverse events with aflibercept treatment compared to controls). 27084563
Mansour AM, Ashraf M, Dedhia CJ, Charbaji A, Souka AAR, Chhablani J. Long-term safety and efficacy of ziv-aflibercept in retinal diseases. Br J Ophthalmol 2017; 101: 1374-6. (Among 55 patients with macular degeneration treated off-label with ziv-aflibercept by intravitreal injection, visual acuity improved and "systemic adverse effects were not registered"). 28270485
Bevacizumab-Ranibizumab International Trials Group. Serious adverse events with bevacizumab or ranibizumab for age-related macular degeneration: meta-analysis of individual patient data. Ophthalmol Retina 2017; 1: 375-81. (Independent review of pooled data from 3052 patients participating in 5 large randomized controlled trials comparing bevacizumab and ranibizumab as therapy of macular degeneration, found rates of systemic serious adverse events to be the same with the two anti-VEGF monoclonal antibodies). 29038796
Thulliez M, Angoulvant D, Pisella PJ, Bejan-Angoulvant T. Overview of systematic reviews and meta-analyses on systemic adverse events associated with intravitreal anti-vascular endothelial growth factor medication use. JAMA Ophthalmol 2018; 136 (5): 557-66. (Review of 21 systematic reviews suggested that intravitreal therapy of macular degeneration is not associated with a higher rate of systemic adverse events). 29566105
Dugel PU, Koh A, Ogura Y, Jaffe GJ, Schmidt-Erfurth U, Brown DM, Gomes AV, et al.; HAWK and HARRIER Study Investigators. HAWK and HARRIER: Phase 3, multicenter, randomized, double-masked trials of brolucizumab for neovascular age-related macular degeneration. Ophthalmology. 2020;127:72-84. (Among 1817 patients with untreated neovascular age-related macular degeneration treated with brolucizumab [3 or 6 mg] or aflibercept [2 mg] by intravitreal injection for 48 weeks, brolucizumab demonstrated non-inferiority to aflibercept in change in best correct visual acuity, and adverse event rates were similar, nonocular hepatobiliary serious adverse events arose in less than 1% of subjects; no details given except that they were considered unrelated to therapy). 30986442
Brolucizumab (Beovu) for age-related macular degeneration. Med Lett Drugs Ther. 2020;62:23-24. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of brolucizumab shortly after its approval as therapy of macular degeneration, no mention of hepatic adverse events). 32022789
Heier JS, Khanani AM, Quezada Ruiz C, Basu K, Ferrone PJ, Brittain C, Figueroa MS, et al.; TENAYA and LUCERNE Investigators. Efficacy, durability, and safety of intravitreal faricimab up to every 16 weeks for neovascular age-related macular degeneration (TENAYA and LUCERNE): two randomised, double-masked, phase 3, non-inferiority trials. Lancet. 2022;399(10326):729-740. (Among 1329 patients with neovascular macular degeneration enrolled in two controlled trials of intravitreal injections of faricimab [6 mg] every 4 to 16 weeks vs aflibercept every 8 weeks for 48 weeks, improvements in visual acuity were similar in both groups as were total and serious adverse events; extra-ocular events arising in 52% vs 55%; no mention of liver related adverse events). 35085502
Wykoff CC, Abreu F, Adamis AP, Basu K, Eichenbaum DA, Haskova Z, Lin H, et al.; YOSEMITE and RHINE Investigators. Efficacy, durability, and safety of intravitreal faricimab with extended dosing up to every 16 weeks in patients with diabetic macular oedema (YOSEMITE and RHINE): two randomised, double-masked, phase 3 trials. Lancet. 2022;399(10326):741-755. (Among 1891 patients with diabetic macular edema enrolled in two controlled trials of intravitreal faricimab [6 mg] every 4 to 18 weeks vs aflibercept [2 mg] every 8 weeks for up to 100 weeks, improvements in visual acuity were similar in the two groups as were total and serious adverse events, extra-ocular events arising in 66% and 57% vs 65% and 60%; no mention of liver related adverse events). 35085503
Faricimab (Vabysmo) for age-related macular degeneration and diabetic macular edema. Med Lett Drugs Ther. 2022;64:45-46. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of faricimab shortly after its approval as therapy of age-related neovascular macular degeneration, no mention of hepatic adverse events). 35294428
Heier JS, Lad EM, Holz FG, Rosenfeld PJ, Guymer RH, Boyer D, Grossi F, et al.; OAKS and DERBY study investigators. Pegcetacoplan for the treatment of geographic atrophy secondary to age-related macular degeneration (OAKS and DERBY): two multicentre, randomised, double-masked, sham-controlled, phase 3 trials. Lancet. 2023;402(10411):1434-1448. (Among 1258 patients with age-related macular degeneration enrolled in two 24 month randomized sham controlled trials of intravitreal injections of pegcetacoplan, there was a 16-22% slowing of growth of geographic atrophy lesions but no differences in visual function or acuity; no mention of ALT levels or hepatic adverse events). 37865470
Brown DM, Nowik M, Bouillaud E, Dugel APU; HAWK Extension Study Investigators. HAWK Extension Study: Safety and efficacy of intravitreal brolucizumab in neovascular age-related macular degeneration. Curr Eye Res. 2023;48:44-50. (Long term follow up of controlled trials of brolucizumab for macular degeneration identified no new safety signals; no mention of hepatic adverse events). 36398628
Pegcetacoplan (Syfovre) for geographic atrophy in age-related macular degeneration. Med Lett Drugs Ther. 2023;65:49-50. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of pegcetacoplan shortly after its approval as therapy of age-related macular degeneration given as intravitreal injections every one to two months, no mention of hepatic adverse events). 37020339
Khanani AM, Patel SS, Staurenghi G, Tadayoni R, Danzig CJ, Eichenbaum DA, Hsu J, et al.; GATHER2 trial investigators. Efficacy and safety of avacincaptad pegol in patients with geographic atrophy (GATHER2): 12-month results from a randomised, double-masked, phase 3 trial. Lancet. 2023;402(10411):1449-1458. (Among 448 patients with age-related macular degeneration and geographic atrophy treated with avacincaptad pegol or sham intravitreal injections monthly for 12 months, the area of atrophy growth was less with avacincaptad and nonocular adverse event rates were similar in the two groups [56% vs 57%] and “laboratory parameters” did not change from baseline). 37696275
Patel SS, Lally DR, Hsu J, Wykoff CC, Eichenbaum D, Heier JS, Jaffe GJ, et al. Avacincaptad pegol for geographic atrophy secondary to age-related macular degeneration: 18-month findings from the GATHER1 trial. Eye (Lond). 2023;37:3551-3557. (Among 286 patients with geographic atrophy due to age-related macular degeneration treated with avacincaptad pegol [2 or 4 mg] or sham intravitreal injections every month for 18 months, mean geographic atrophy growth was 28% and 30% less with avacincaptad, and systemic adverse event rates were similar between groups [61% and 64% vs 60%] and none were considered drug related). 36964259
Avacincaptad pegol (Izervay) for geographic atrophy in age-related macular degeneration. Med Lett Drugs Ther. 2024;66:15-16. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of avacincaptad pegol shortly after its approval as therapy of geographic atrophy in age-related macular degeneration; no mention of hepatic adverse events). 38212259

## OTHER REFERENCE LINKS

1. Recent References on Aflibercept: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Aflibercept+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Recent References on Bevacizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bevacizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

3. Recent References on Brolucizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Brolucizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

4. Recent References on Faricimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Faricimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

5. Recent References on Pegaptanib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pegaptanib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

6. Recent References on Ranibizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ranibizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

7. Recent References on Avacincaptad pegol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Avacincaptad+pegol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

8. Recent References on Pegcetacoplan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pegcetacoplan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

9. Trials on Aflibercept: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Aflibercept&viewType=Table)

10. Trials on Bevacizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bevacizumab)

11. Trials on Brolucizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Brolucizumab&viewType=Table)

12. Trials on Faricimab: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Faricimab&viewType=Table)

13. Trials on Pegaptanib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pegaptanib)

14. Trials on Ranibizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ranibizumab)

15. Trials on Avacincaptad pegol: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Avacincaptad%20pegol&viewType=Table)

16. Trials on Pegcetacoplan: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Pegcetacoplan&viewType=Table)